# Asciminib

## OVERVIEW

### Introduction

Asciminib is a tyrosine kinase inhibitor that specifically targets myristoyl pocket of ABL1 and is used to treat refractory forms of Philadelphia chromosome positive chronic myelocytic leukemia. Serum aminotransferase elevations occur in a proportion of patients treated with asciminib, but episodes of clinically apparent liver injury with jaundice have not been reported with its use.

### Background

Asciminib (as kim’ in ib) is an orally available, tyrosine kinase inhibitor that targets the myristoyl pocket of ABL1 resulting in inhibition of the abnormal fusion kinase BCR-ABL1 that drives cellular proliferation in chronic myelocytic leukemia (CML) associated with the Philadelphia chromosome (Ph+). The Philadelphia chromosome is an acquired genetic abnormality of chromosome 22 found in leukemic cells, which is created by a reciprocal translocation between chromosomes resulting in a fusion gene of ABL1 (for Abelson leukemia virus) from chromosome 9 and the breakpoint cluster region (BCR) of chromosome 22. The translocated gene creates a hybrid tyrosine kinase receptor that is continuously synthesized in an active form causing uncontrolled growth and proliferation of the affected cell. Referred to as a STAMP positive tyrosine kinase receptor inhibitor, asciminib specifically targets the ABL1 myristoyl pocket and has separate activity and resistance patterns compared to conventional anti-BCR-ABL1 kinases that target the catalytic site of the abnormal BCR-ABL1 kinase. Asciminib has potent specificity against the T315I mutant of ABL1 that is resistant to standard tyrosine kinase inhibitors used to treat CML, such as imatinib, sunitinib, nilotinib, bosutinib, ponatinib, and regorafenib, the first-, second-, and third-line therapies of Ph+ CML. Asciminib was granted accelerated approval in the United States in 2021 for adults with refractory or relapsed CML after therapy with at least two conventional BCR-ABL1 kinase inhibitors and in high doses for refractory cases harboring the T315I mutant. Asciminib is available in tablets of 20 and 40 mg under the brand name Scemblix. The recommended oral dose varies by indication, being 40 mg twice or 80 mg once daily for refractory cases of Ph+ CML, but 200 mg twice daily for cases harboring the highly resistant T315I mutation. Therapy should continue until disease progression or unacceptable toxicity. Side effects are dose related, but at the highest dose are common, arising in almost all patients. Common side effects include anemia, neutropenia, myelosuppression, musculoskeletal pain, fatigue, headache, rash, and diarrhea. Less common but potentially severe adverse events include severe myelosuppression, pancreatitis, hypertension, hypersensitivity reactions, cardiovascular toxicity, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of asciminib in patients with refractory and extensively treated CML, ALT elevations arose in 13% of patients but were usually self-limited and mild. ALT elevations above 5 times the upper limit of normal (ULN) were uncommon, being found in 3% of treated patients. The ALT elevations were typically transient and rarely required dose interruption or modification. In the open label and controlled trials supporting the approval of asciminib, there were no instances of clinically apparent liver injury, hepatic failure or deaths from liver injury. Furthermore, patients with aminotransferase elevations during therapy with first and second line BCR-ABL1 inhibitors did not have an increased rate of such elevations during asciminib therapy. Since its approval in the United States and Europe, there have been no reported cases of clinically apparent liver injury associated with asciminib therapy.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from asciminib is unknown, but the pattern of abnormalities suggests a mild degree of direct hepatotoxicity. Asciminib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4 and 2C9 and is susceptible to drug-drug interactions with agents that inhibit or induce the CYP enzyme reactivity. Asciminib itself inhibits CYP 3A4 and P-glycoprotein and can result in increased levels of drugs that are substrates of these hepatic metabolizing and transport proteins.

### Outcome and Management

The product label for asciminib does not recommend routine monitoring of liver laboratory tests during therapy. Serum aminotransferase elevations above 5 times ULN (if detected) should lead to dose reduction or temporary cessation of treatment with careful monitoring if restarted after resolution of the abnormalities. Elevations of aminotransferase levels accompanied by jaundice or symptoms of liver injury should trigger permanent discontinuation of therapy. Cross sensitivity to liver injury is uncommon among the antineoplastic, small molecule enzyme and receptor inhibitors and in preregistration trials, shared liver injury sensitivity between asciminib and other antineoplastic BCR-ABL1 inhibitors was not found.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Asciminib – Scemblix®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Asciminib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Asciminib | 1492952-76-7 | C20-H19-Cl2-F2-N5-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 08 October 2023

Abbreviations: ABL1, Abelson leukemia virus 1 protein; BCR, breakpoint cluster region; TKI, tyrosine kinase inhibitor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss asciminib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/215358Orig1s000,Orig2s000MultidisciplineR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of asciminib; describes the adverse events observed in a pooled safety population of 356 patients of whom 96% had at least one adverse event which were scored as serious in 21% and included ALT elevations 13% which were above 5 times ULN in 3%, but the elevations were often single values and none were associated with jaundice and there were no instances of hepatic failure, or fatalities due to liver injury).
Hughes TP, Mauro MJ, Cortes JE, Minami H, Rea D, DeAngelo DJ, Breccia M, et al. Asciminib in chronic myeloid leukemia after ABL kinase inhibitor failure. N Engl J Med. 2019;381:2315-2326. (Among 150 adults with CML refractory to at least two conventional BCR-ABL1 targeted tyrosine kinase inhibitors [TKIs] who were treated with asciminib in varying doses for 12 months, 48% had a major molecular response and adverse events were frequent, most commonly fatigue, headache, arthralgias, hypertension and decreases in platelet counts, with ALT elevations in 11% that were above 5 times the ULN in 3%; no mention of clinically apparent liver injury or hepatotoxicity). 31826340
Réa D, Mauro MJ, Boquimpani C, Minami Y, Lomaia E, Voloshin S, Turkina A, et al. A phase 3, open-label, randomized study of asciminib, a STAMP inhibitor, vs bosutinib in CML after 2 or more prior TKIs. Blood. 2021;138:2031-2041. (Among 233 adults with Ph+ CML refractory to at least two conventional BCR-ABL1 TKIs treated with asciminib [40 mg twice daily] vs bosutinib [500 mg once daily] for a median of 15 months, the week 24 major molecular response rates were 26% vs 13%, while adverse events occurred in 90% vs 96% which required discontinuation in 6% vs 21%, and ALT elevations arose in 4% vs 28% and were above 5 times ULN in 0.6% vs 15%, but there were cases of clinically apparent liver injury in those receiving asciminib). 34407542
Hochhaus A, Réa D, Boquimpani C, Minami Y, Cortes JE, Hughes TP, Apperley JF, et al. Asciminib vs bosutinib in chronic-phase chronic myeloid leukemia previously treated with at least two tyrosine kinase inhibitors: longer-term follow-up of ASCEMBL. Leukemia. 2023;37:617-626. (Among the 233 adults with TKI refractory Ph+ CML treated with asciminib or bosutinib [Rea et al 2021], longer follow up to a median of 2.3 years continued to show the greater major molecular response rate with asciminib [38% vs 16% at week 96] while adverse event rates were less, ALT elevations in 4.5% vs 30% which were above 5 times ULN in 0.6% vs 14.5%). 36717654
Luna A, Pérez-Lamas L, Boque C, Giraldo P, Xicoy B, Ruiz Nuño C, Vega MM, et al. Real-life analysis on safety and efficacy of asciminib for ponatinib pretreated patients with chronic myeloid leukemia. Ann Hematol. 2022;101:2263-2270. (Among 52 Spanish adults with refractory Ph+ CML previously treated BCR-ABL1 targeted TKIs [including ponatinib] who were switched to asciminib, 52% had a major molecular response while half developed an adverse event on therapy; no mention of ALT elevations or hepatotoxicity). 35997804
Tesileanu CMS, Michaleas S, Gonzalo Ruiz R, Mariz S, Fabriek BO, van Hennik PB, Dedorath J, et al. The EMA assessment of asciminib for the treatment of adult patients with Philadelphia chromosome-positive chronic myeloid leukemia in chronic phase who were previously treated with at least two tyrosine kinase inhibitors. Oncologist. 2023;28:628-632. (Summary of the basis for the approval of asciminib for use in CML by the European Medicines Agency mentions that hepatotoxicity and reactivation of hepatitis B “were considered important potential risks”). 37141403
Pérez-Lamas L, Luna A, Boque C, Xicoy B, Giraldo P, Pérez López R, Ruiz Nuño C, et al. Toxicity of asciminib in real clinical practice: analysis of side effects and cross-toxicity with tyrosine kinase inhibitors. Cancers (Basel). 2023;15:1045. (Further analysis of Spanish adults with previously TKI-refractory Ph+ CML who were switched to asciminib therapy included data on 77 patients with a median follow up of 14 months, 55% had at least one adverse event, most being less frequent that with previous TKIs, ALT elevations arose in 2 patients which were above 5 times ULN in one). 36831388
Asciminib (Scemblix) for chronic myeloid leukemia. Med Lett Drugs Ther. 2023;65:e107-e108. (Brief review of the mechanism of action, clinical efficacy, safety and cost of asciminib shortly after its approval in the US as therapy of CML refractory of conventional BCR-ABL1 targeted TKIs mentions that ALT, triglyceride, creatinine, amylase and lipase elevations can occur during therapy). 37339100

## OTHER REFERENCE LINKS

Recent References on Asciminib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Asciminib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Asciminib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Asciminib)